# Sedatives and Hypnotics

## OVERVIEW

Drugs for insomnia, which are also known as sedatives, hypnotics, medications for sleep, sleeping aids or more colloquially “sleeping pills”, are some of the most commonly used medications, both by prescription and over-the-counter. Insomnia affects up to 20% of the adult population and can be transient (<3 days), short term (3 to 30 days), or long term and chronic. Insomnia is also categorized as either primary or secondary. The drugs for insomnia are typically used for a short time only and act to decrease the latency to onset of sleep or prevent early awakening. They may improve the quality of sleep as assessed subjectively, but they usually do not usually increase sleep duration.

In many situations, insomnia need not be treated with medications; good sleep hygiene, adequate exercise, avoidance of alcohol and caffeine, and attention to the details of regular sleep habits can improve insomnia in many patients. Furthermore, while medications can be effective in the short term, they sometimes worsen or perpetuate insomnia when used for long periods.

Several types of medications are used to treat insomnia or as sleeping aids, including barbiturates, antihistamines, various herbals, benzodiazepines and benzodiazepine receptor analogues. Currently, the benzodiazepine receptor analogues are the most frequently used drugs for insomnia and have perhaps the best record for safety and efficacy. The majority of sleeping aids have not been linked to liver injury, either in the form of clinically apparent acute liver injury or in causing transient serum enzyme elevations.

Drugs for insomnia are also referred to as sedatives, even tranquillizers. The various agents used to treat insomnia or as sleeping aids or sedatives are each described separately with annotated references.

Drug Class: Sedatives and Hypnotics; Drugs for Insomnia

Subclasses:

- Antihistamines
  - Diphenhydramine
  - Doxylamine
  - Hydroxyzine
- Barbiturates
  - Amobarbital
  - Butabarbital
  - Phenobarbital
  - Secobarbital
- Benzodiazepines
  - Alprazolam
  - Diazepam
  - Estazolam
  - Flurazepam
  - Quazepam
  - Remimazolam
  - Temazepam
  - Triazolam
- Benzodiazepine Receptor Agonists
  - Eszopiclone
  - Zaleplon
  - Zolpidem
- Herbals
  - Chamomile (Matricaria recutita)
  - Hops (Humulus lupulus)
  - Lavender (Lavandula angustifolia)
  - Passionflower (Passiflora incarnata)
  - Valerian (Valeriana officinalis)
- Melatonin and its Analogues
  - Melatonin
  - Ramelteon
  - Tasimelteon
- Orexin Receptor Antagonists
  - Daridorexant
  - Lemborexant
  - Suvorexant
- Miscellaneous Agents
  - Buspirone
  - Chloral Hydrate
  - Doxepin
  - Meprobamate
  - Oxybate (Narcolepsy Agent)

## ANNOTATED BIBLIOGRAPHY

References updated: 10 February 2025

Zimmerman HJ. Anxiolytic agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 491-3. (Expert review of hepatotoxicity published in 1999 discusses benzodiazepines and minor tranquilizers: "In general, the hepatotoxic potential of this widely used group of compounds seems low").
Larrey D, Ripault MP. Anxiolytic agents. Hepatotoxicity of psychotropic drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, p. 455-6. (Review of hepatotoxicity published of anxiolytic agents discusses benzodiazepines, buspirone and valerian, all of which have been linked to rare cases of liver injury).
Mihic SJ, Harris RA. Hypnotics and sedatives. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 457-80. (Textbook of pharmacology and therapeutics).
Terzano MG, Rossi M, Palomba V, Smerieri A, Parrino L. New drugs for insomnia: comparative tolerability of zopiclone, zolpidem and zaleplon. Drug Saf 2003; 26: 261-82. (Comparison of adverse events and tolerability of three new drugs for insomnia focusing upon CNS symptoms such as headache, drowsiness and fatigue; mentions rare observations suggestive of hepatotoxicity of zolpidem [Karsenti 1999]). 12608888
Drover DR. Comparative pharmacokinetics and pharmacodynamics of short-acting hypnosedatives: zaleplon, zolpidem and zopiclone. Clin Pharmacokinet 2004; 43: 227-38. (Review of mechanism of action, pharmacology, efficacy and adverse effects of 3 nonbenzodiazepine hypnotic agents: zaleplon, zolpidem and zopiclone). 15005637
Ramelteon (Rozerem) for insomnia. Med Lett Drugs Ther 2005; 47 (1221): 89-91. (Concise summary of mechanism of action, pharmacology, efficacy and safety of ramelteon for insomnia, published shortly after its approval in the US, mentions that high doses in rats caused liver cancers, but no mention of hepatotoxicity in humans). 16267494
Eszopiclone (Lunesta), a new hypnotic. Med Lett Drugs Ther 2005; 47 (1203): 17-9. (Concise summary of mechanism of action, pharmacokinetics, efficacy and safety of eszopiclone for insomnia published shortly after its approval in the US; no mention of change in ALT levels or hepatotoxicity). 15767972
Drug for insomnia. Treat Guidel Med Lett 2012; 10 (119): 57-60. (Guideline recommendations for therapy of insomnia; mentions that benzodiazepine receptor agonists, benzodiazepines, ramelteon and low doses of doxepin are effective and generally safe; among adverse events, no mention of ALT elevations or hepatotoxicity of any of the recommended agents). 22777275
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none were attributed to a sleeping aid, despite the fact that zopiclone and zolpidem are among the 25 most commonly prescribed drugs in Iceland). 23419359
FDA. https://www.fda.gov/downloads/Drugs/DrugSafety/UCM335007.pdf (FDA letter warning of the next-morning impairment including driving ability after use of insomnia drugs and recommendation of use of lower doses, particularly for women).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, but none were attributed to sedatives or sleeping aids). 24552865
Douros A, Bronder E, Andersohn F, Klimpel A, Thomae M, Sarganas G, Kreutz R, et al. Drug-induced liver injury: results from the hospital-based Berlin Case-Control Surveillance Study. Br J Clin Pharmacol 2015; 79: 988-99. (Among 76 cases of suspected drug induced liver injury and 377 controls enrolled in a German, prospective hospital based registry, 9 cases but also 15 controls had been exposed to zolpidem, a difference that was not statistically significant). 25444550
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 82 [9%] were attributed to agents active in the central nervous system, but none were sedatives or sleeping aids). 25754159
Suvorexant (Belsomra) for insomnia. Med Lett Drugs Ther 2015; 57 (1463): 29-31. (Concise review of the efficacy, safety and costs of suvorexant as therapy of insomnia shortly after its approval in the US, mentions the most common side effect as being next day somnolence [in 7-13% of recipients]; no mention of hepatotoxicity or ALT elevations). 25719996
Lemborexant (Dayvigo) for insomnia. Med Lett Drugs Ther. 2020;62:97-100. (Concise review of the mechanism of action, clinical efficacy, safety and costs of lemborexant, mentions side effects of somnolence, headaches, abnormal dreams, depression, suicidal ideation, and sleep paralysis and cataplexy, but no mention of ALT elevations or hepatotoxicity). 32724021
Daridorexant (Quviviq) for insomnia. Med Lett Drugs Ther. 2022;64:107-110. (Concise summary of the mechanism of action, clinical efficacy, safety, and costs of daridorexant shortly after its approval as therapy for insomnia in the US mentions adverse events of headache, somnolence, and fatigue [5-7%] and more rarely daytime sleepiness, sleep paralysis, and hallucinations [<1%]; no mention of ALT elevations or hepatotoxicity). 35802843
Drugs for chronic insomnia. Med Lett Drugs Ther. 2023;65:1-6. (Concise description of drugs approved for use in chronic insomnia including relative efficacy, safety and costs, including benzodiazepine receptor agonists, benzodiazepines, melatonin receptor agonists, orexin receptor antagonists and other agents including nonprescription and herbal products, mentions that the orexin receptor inhibitors improve latency to falling asleep by 5-10 minutes and duration of sleep to waking by 15-25 minutes compared to placebo and that their most common adverse events are somnolence, fatigue, headache, and abnormal dreams). 36630579

## OTHER REFERENCE LINKS

Recent References on DRUGNAME: from PubMed.gov (https://www.ncbi.nlm.nih.gov/)

Trials on DRUGNAME: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Benzodiazepine)